# Prochlorperazine

## OVERVIEW

### Introduction

Prochlorperazine is a phenothiazine used primarily as an antiemetic agent. In rare instances, prochlorperazine can cause clinically apparent acute and chronic cholestatic liver injury.

### Background

Prochlorperazine (proe" klor per' a zeen) is a tricyclic aliphatic phenothiazine which acts by postsynaptic inhibition of dopamine receptors. Prochlorperazine has other peripheral and central nervous system effects, producing both alpha adrenergic stimulation and blocking histamine- and serotonin-mediated effects. Prochlorperazine is indicated primarily for the therapy of nausea and vomiting. Prochlorperazine also has antianxiety and antipsychotic effects, but is used less commonly for these indications compared to the major phenothiazines such as chlorpromazine, fluphenazine, perphenazine, thioridazine and trifluoperazine. Prochlorperazine was approved for use in the United States in 1956 and is still widely used in therapy of nausea and vomiting. Prochlorperazine is available in generic forms as tablets of 5, 10 and 25 mg, in long acting capsules of 15 mg, as an oral solution of 5 mg/ 5 mL, as suppositories of 2.5, 5 and 25 mg, and in parenteral forms. Prochlorperazine is also available under the brand names of Compazine and Compro. Typical doses for nausea are 5 to 10 mg three to four times daily. Common side effects are similar to other phenothiazines and include drowsiness, dizziness, headache, blurred vision, dry mouth, constipation, tremor, restlessness, muscle spasms and weight gain. Rare but potentially severe adverse events (which apply to most antipsychotic agents) include an increased risk for death in the elderly with dementia-related psychosis, neuroleptic malignant syndrome, tardive dyskinesia and orthostatic hypotension.

### Hepatotoxicity

Liver test abnormalities are uncommon during prochlorperazine therapy, perhaps because it is rarely given long term or in high doses chronically. Aminotransferase elevations can occur during therapy, but they are usually mild, asymptomatic and transient and reversible even with continuation of medication. Rare instances of clinically apparent acute liver injury have been reported due to prochlorperazine which resemble the cholestatic liver injury associated with chlorpromazine. The onset of jaundice is usually within 1 to 4 weeks, and the pattern of serum enzyme elevations is typically cholestatic or mixed. Immunoallergic features (fever and eosinophilia) occur in some cases, but they are usually mild and self-limited; autoantibodies are rare. Liver biopsy typically shows a cholestatic hepatitis. Importantly, prochlorperazine jaundice can be prolonged and has been associated with rare cases of vanishing bile duct syndrome (Case 1) that can be fatal or ultimately require liver transplantation.

Likelihood score: B (uncommon but likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which prochlorperazine causes serum aminotransferase elevations is not known but is likely shared with other phenothiazines. Several features of the clinical presentation of prochlorperazine hepatotoxicity (short latency period, fever, eosinophilia) suggest a hypersensitivity reaction, and rechallenge typically causes a rapid recurrence of injury. Prochlorperazine is extensively metabolized by the liver via sulfoxidation and oxidation, and some instances of serum aminotransferase elevations as well as more clinically apparent liver injury may be caused by production of a toxic intermediate of its metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on prochlorperazine therapy are usually transient and do not require dose modification or discontinuation of therapy. The acute cholestatic hepatitis caused by prochlorperazine is typically self-limited and benign but should prompt immediate discontinuation. A small proportion of cases are followed by prolonged jaundice and cholestasis and features of vanishing bile duct syndrome. Many patients with chronic cholestasis eventually improve, but they may have persistent enzyme elevations and biliary cirrhosis. Fatalities from prochlorperazine jaundice have been reported. Rechallenge with phenothiazines usually causes a prompt recurrence of the liver injury and should be avoided.

Drug Class: Gastrointestinal Agents; Antipsychotic Agents

Other Drugs in the Subclass, Phenothiazines: Chlorpromazine, Fluphenazine, Perphenazine, Thioridazine, Trifluoperazine

## CASE REPORT

### Case 1. Prolonged cholestatic liver injury due to prochlorperazine.(1)

A 68 year old man was treated with trimethoprim/sulfamethoxazole (800/400 mg three times daily) for one week and prochlorperazine (10 mg daily) for 4 weeks for suspected otitis media. A few weeks after stopping prochlorperazine, he developed jaundice and pruritus. When first seen, one month after stopping medications, serum bilirubin was 18.4 mg/dL, alkaline phosphatase was 1.5 times normal and ALT was minimally elevated (Table). Tests for viral hepatitis and abdominal ultrasound were normal. After persistence of jaundice for 3 months, a liver biopsy was done which showed centrilobular cholestasis with minimal hepatocyte necrosis or portal inflammation. The intralobular bile ducts were normal. He continued to have jaundice and severe pruritus and developed skin hyperpigmentation. Tests for hepatitis B and mitochondrial antibody were negative. Endoscopic retrograde cholangiopancreatography was normal. Serum bilirubin levels peaked 4 months after presentation and then began to decline, not becoming normal until one year later. Pruritus and hyperpigmentation also resolved, but serum alkaline phosphatase and GGT levels remained elevated. A repeat liver biopsy, done two years after onset and 9 months after resolution of jaundice and symptoms, showed minimal cholestasis but bridging hepatic fibrosis and paucity of intralobular bile ducts. Two-and-a-half years after onset, serum alkaline phosphatase levels were still abnormal but he had no symptoms.

#### Key Points

Medication: | Prochlorperazine (10 mg daily for 4 weeks)
Pattern: | Cholestatic
Severity: | 4+ (prolonged jaundice and hepatic fibrosis)
Latency: | 3 weeks
Recovery: | Incomplete after 2 years
Other medications: | Trimethoprim/sulfamethoxazole

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Comments
| | Chlorpromazine (50 mg daily) given for nausea for 4 weeks
1 month | 0 | 49 | 116 | 18.4
| 3 months | 80 | 210 | 26.2 | Biopsy #1
| 4 months | 88 | 219 | 19.3 | ERCP normal
| 6 months | 85 | 365 | 11.2
| 10 months | 65 | 430 | 2.6
1 year | 12 months | 60 | 410 | 1.5
2 years | 22 months | 85 | 445 | 1.0 | Biopsy #2
Normal Values | | <42 | <90 | <1.2

* Some values estimated from Figure 1 and bilirubin converted from μmol/L to mg/dL.

#### Comment

A typical example of the evolution of an acute cholestatic hepatitis to prolonged cholestasis and vanishing bile duct syndrome. The patient eventually improved and was asymptomatic, but alkaline phosphatase levels were persistently elevated and liver biopsy showed paucity of intralobular bile ducts and bridging hepatic fibrosis. Not all cases of vanishing bile duct syndrome progress to hepatic failure and eventual clinical improvement is common. Long term follow up on such cases usually demonstrates well compensated and nonprogressive cirrhosis and persistence of mild elevations in serum alkaline phosphatase.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Prochlorperazine – Generic, Compazine®, Compro®

DRUG CLASS

Gastrointestinal Agents; Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Prochlorperazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Prochlorperazine | 58-38-8 | C20-H24-Cl-N3-S

## CITED REFERENCE

1 Lok AS, Ng IO. (1988). Prochlorperazine-induced chronic cholestasis. J Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2020

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including chlorpromazine published in 1999; several hundred cases of chlorpromazine jaundice have been reported, usually cholestatic, arising after 1-5 weeks, often with fever and eosinophilia, sometimes causing vanishing bile duct syndrome; other phenothiazines have only rarely been linked to liver injury, except for prochlorperazine).
Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 447-62. (Review of phenothiazine hepatotoxicity mentions that liver enzyme elevations arise in up to 40% of patients, and hundreds of cases of chlorpromazine jaundice have been published with a frequency of 0.5-1%, onset within 2-5 weeks and usually presenting with acute cholestatic hepatitis with jaundice and pruritus and a prolonged course in 7%; other phenothiazines have been linked to liver injury similar to that of chlorpromazine, “but with a lower frequency” ).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Mechanic RC, Meyers L. (1958). Chlorpromazine-type cholangitis; report of a case occurring after the administration of prochlorperazine. N Engl J Med. (68 year old woman developed jaundice within 10 days of starting once daily prochlorperazine for nausea [peak bilirubin 26.8 mg/dL, AST 77 U/L, Alk P ~3 fold elevated], resolving slowly after stopping and undergoing laparotomy for suspected extrahepatic biliary obstruction).
Milne HB, Berliner F. (1958). A clinical trial of Stemetil (prochlorperazine). J Ment Sci.
Solomon FA, Campagna FA. (1959). Jaundice due to prochlorperazine (Compazine). Am J Med. (50 year old female developed jaundice 5 days after restarting prochlorperazine for nausea [bilirubin 19.2 mg/dL, Alk P ~20 times ULN]; biopsy showed intrahepatic cholestasis similar to chlorpromazine jaundice).
Crandell A, Ma JY. (1959). Jaundice precipitated by prochlorperazine (Compazine) in the treatment of alcoholic psychiatric disturbance. J Med Soc N J. (26 year old man with alcoholism and tuberculosis developed fever and jaundice 24 days after starting a third course of prochlorperazine; serum enzyme and bilirubin levels were not provided).
Weinstein A, Alper B, Dade J. (1959). Cholestasis due to prochlorperazine. J Am Med Assoc. (49 year old woman developed nausea and pruritus 3 weeks after starting prochlorperazine [bilirubin 4.7 mg/dL, AST 75 U/L, Alk P ~2x ULN], biopsy showing intrahepatic cholestasis and resolving within 3-4 weeks of stopping).
Salde H, Wallindr J. (1961). Svenska Lakartidningen. (Analysis of 40 patients treated with prochlorperazine for psychosis; major side effects were sedation and extrapyramidal symptoms; no jaundice reported).
McQueen EG. (1963). Toxic effects of phenothiazine tranquillizers. N Z Med J. (Review of the phenothiazines and their side effects; “Jaundice has occurred in about 1% of patients taking chlorpromazine, and also, although less frequently, in patients taking one of the more recently developed analogues”).
McFarland RB. (1963). Fatal drug reaction associated with prochlorperazine (Compazine). Report of a case characterized by jaundice, thrombocytopenia, and agranulocytosis. Am J Clin Pathol. (73 year old woman hospitalized for suspect myocardial infarction was given prochlorperazine and developed fever 31 days later with thrombocytopenia [bilirubin 2.8 mg/dL, AST 1480 U/L]; prochlorperazine was stopped, but she worsened and died of multiorgan failure 2 weeks later, autopsy showed centrolobular necrosis).
Cook GC, Sherlock S. (1965). Jaundice and its relation to therapeutic agents. Lancet. (Summary of cases of drug induced liver disease seen at Royal Free Hospital between 1959-65; 11 cases of acute liver failure including 3 due to iproniazid, 2 phenelzine, 2 phenoxypropazine, 1 prochlorperazine and 3 halogenated anesthetics; 20 cases of cholestatic hepatitis including 18 due to chlorpromazine, 1 perphenazine and 1 nitrofurantoin).
Walker CO, Combes B. (1966). Biliary cirrhosis induced by chlorpromazine. Gastroenterology. (Two patients, a 32 year old woman and a 31 year old man, developed persistent jaundice [>4 years], cholestasis and liver fibrosis 3 and 4 weeks after starting chlorpromazine; acute cholestatic hepatitis evolving into chronic form with biopsies showing cirrhosis and complications of portal hypertension).
(1967). Case records of the Massachusetts General Hospital. Case 32-1967. N Engl J Med. (86 year old woman with complicated course after cholecystectomy resulting in multiorgan failure; autopsy showing “toxic hepatitis” and prochlorperazine considered a possible cause).
Ishak KG, Irey NS. (1972). Hepatic injury associated with the phenothiazines. Clinicopathologic and follow-up study of 36 patients. Arch Pathol. (Review of 36 liver biopsies of phenothiazine induced hepatotoxicity from the files of the Armed Forces Institute of Pathology; 33 due to chlorpromazine, 3 prochlorperazine; mean onset 15 days, eosinophilia in 73%, mean bilirubin 12.4 mg/dL, Alk P ~8 fold elevated, ALT 146 U/L; 6 [17%] had prolonged course for 10-16 months).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, 51 were attributed to chlorpromazine [9%, ranking 2nd behind halothane], latency averaging 14 days [range 11-46]; 5 deaths; no other phenothiazines mentioned).
Kaplowitz N, Aw TY, Simon FR, Stolz A. (1986). Drug-induced hepatotoxicity. Ann Intern Med. (Review of drug induced hepatotoxicity including phenothiazine jaundice).
Munyon WH, Salo R, Briones DF. (1987). Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl). (In vitro assay for cytotoxicity of 8 neuroleptic drugs found that chlorpromazine was more toxic than haloperidol and loxapine, but similar to other phenothiazines).
Regal RE, Bili JE, Glazer HM. (1987). Phenothiazine-induced cholestatic jaundice. Clin Pharm. (Review of phenothiazine induced liver injury; cross sensitivity is rare “but does exist”).
Lok AS, Ng IO. (1988). Prochlorperazine-induced chronic cholestasis. J Hepatol. (68 year old man developed jaundice 4 weeks after starting prochlorperazine [peak bilirubin 26 mg/dL, ALT 50-90 U/L, Alk P 120-500 U/L], jaundice and pruritus persisting for more than a year, but then gradual clinical improvement but with persistent enzyme elevations, and biopsy 22 months after onset showed fibrosis and paucity of bile ducts: Case 1).
Bach N, Thung SN, Schaffner F, Tobias H. (1989). Exaggerated cholestasis and hepatic fibrosis following simultaneous administration of chlorpromazine and sodium valproate. Dig Dis Sci. (45 year old man developed fatigue and fever 12 days after starting chlorpromazine for hiccups [bilirubin 21.5 mg/dL, ALT 1312 U/L, Alk P 617 U/L], with persistent jaundice and pruritus for several years and eventual presence of cirrhosis and varices; paucity of bile ducts on biopsy).
Pillans PI. (1996). Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J. (Over 21 year period in New Zealand, there were 943 official reports of liver injury involving 205 drugs; chlorpromazine was in the top 20 drugs implicated accounting for 2.7% of cases; prochlorperazine was cause of 4 cases, but other phenothiazines not mentioned).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993 and 2000, 3 were due to chlorpromazine with relative risk of 613: frequency of 261 per 100,000 person year exposures; no other phenothiazine mentioned).
Mindikoglu AL, Anantharaju A, Hartman GG, Li SD, Villanueva J, Van Thiel DH. (2003). Prochlorperazine-induced cholestasis in a patient with alpha-1 antitrypsin deficiency. Hepatogastroenterology. (58 year old woman 9 years after lung transplant for alpha-1-antitrypsin deficiency on multiple medications including prochlorperazine for 27 months developed jaundice and chronic allograft rejection [peak bilirubin 38.6 m/dL, ALT 71 U/L, Alk P 362 U/L]; drug stopped, but only 3 days of follow up provided).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were due to phenothiazines).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none to phenothiazines).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine but none to prochlorperazine).
Marwick KF, Taylor M, Walker SW. (2012). Antipsychotics and abnormal liver function tests: systematic review. Clin Neuropharmacol. (Systematic review of the literature found rates of any serum enzyme elevation during antipsychotic therapy to range from 5-78% and "clinically significant' elevations in 0-15%; lists 12 reports of clinically apparent liver injury due to prochlorperazine, one of which was fatal [McFarland 1963]).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to chlorpromazine, the only antipsychotic medication listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.6%] were attributed to antipsychotic agents, including 3 due to quetiapine and 2 to olanzapine, but none to prochlorperazine or other phenothiazines]).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; the phenothiazines are discussed but not prochlorperazine).
Schreiner NM, Windham S, Barker A. (2017). Atypical neuroleptic malignant syndrome: diagnosis and proposal for an expanded treatment algorithm: a case report. A A Case Rep. (48 year old man with bipolar disorder and NASH underwent liver transplantation and developed confusion, dyskinesia, rigidity, hyperthermia and tachycardia/tachypnea postoperatively having been given lithium, lamotrigine, promethazine and ziprasidone, responding to therapy of neuroleptic malignant syndrome with benzodiazepines and propofol).
Baeza I, de la Serna E, Calvo-Escalona R, Merchán-Naranjo J, Rodríguez-Latorre P, Martínez-Cantarero MC, Andrés P, et al. (2018). One-year prospective study of liver function tests in children and adolescents on second-generation antipsychotics: is there a link with metabolic syndrome?. J Child Adolesc Psychopharmacol. (Among 216 children and adolescents starting atypical antipsychotics, mean weight gain at 6 months was 6.5 kg and mean ALT levels increased by 8.6 U/L, while among 37 taking olanzapine mean weight gain was 10.3 kg and ALT increase 2.6 U/L; increases in ALT associated with development of the metabolic syndrome, mean ALT increasing by 27.8 U/L at 6 months).
Ouellette L, Judge B, Zamarripa A, McFadden P, Jones J. (2019). Safety and effectiveness of intravenous prochlorperazine for intractable vomiting in children with gastroenteritis. Am J Emerg Med. (Among 390 children with acute gastroenteritis given a single infusion of prochlorperazine, 92% had relief of nausea within 3 hours and only 24 [6%] required a second dose; adverse reactions included akathisia/dystonia in 3% to 4%, no mention of ALT elevations or hepatotoxicity).
Golikhatir I, Cheraghmakani H, Bozorgi F, Jahanian F, Sazgar M, Montazer SH. (2019). The efficacy and safety of prochlorperazine in patients with acute migraine: a systematic review and meta-analysis. Headache. (In a systematic review of 11 controlled trials in patients with migraine headaches, prochlorperazine was more effective than placebo and other comparators, and adverse events included akathisia, dystonia, drowsiness and orthostatic hypotension; no mention of ALT elevations or hepatotoxicity).
Haldipur D, Krishnamurthy N, A B. (2020). The real-world safety and effectiveness of prochlorperazine in Indian patients with dizziness. J Assoc Physicians India. (Among 500 patients treated with prochlorperazine [5 mg three times daily for 7 days], dizziness improved in most and only three patients reported adverse events: somnolence, headache and fatigue).

## OTHER REFERENCE LINKS

1 Recent References on Prochlorperazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Prochlorperazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Prochlorperazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Prochlorperazine)